# Colchicine

## OVERVIEW

### Introduction

Colchicine is a plant alkaloid that is widely used for treatment of gout. Colchicine has not been associated with acute liver injury or liver test abnormalities except with serious overdoses.

### Background

Colchicine (kol' chi seen) is an ancient medication that has been used for the treatment of gout for centuries. Colchicine is a plant alkaloid derived from several members of the lily family, including meadow saffron or autumn crocus (originally found in the district of Colchis and called colchicum). Colchicine inhibits microtubule and spindle formation and is believed to act by interference with leukocyte migration to the site of uric acid crystal formation, thereby reducing production of inflammatory mediators. Colchicine does not lower serum and tissue uric acid levels, but is effective in relieving the pain and swelling of acute gout. Colchicine was officially approved for use in the United States in 1961 and it is still widely used with several million prescriptions filled yearly. Current indications include therapy of acute attacks of gout and as maintenance therapy in combination with other agents to prevent attacks. Colchicine is available in multiple generic forms in tablets of 0.5 and 0.6 mg, as well as in fixed combinations with probenecid. The usual adult dose of colchicine is one tablet daily or every other day. Parenteral preparations for intravenous use are also available. Colchicine is also used for familial Mediterranean fever and prevention of amyloidosis. Colchicine has a narrow therapeutic window and side effects are common, particularly with high doses. Common complaints include gastrointestinal upset, diarrhea, nausea, vomiting and hypersensitivity reactions. Overdosage can be fatal.

### Hepatotoxicity

Chronic therapy with colchicine is uncommonly associated with serum aminotransferase or alkaline phosphatase elevations and has, indeed, been used off label as therapy of liver diseases, including alcoholic hepatitis and primary biliary cirrhosis. Despite decades of wide spread use, there have been no published cases of idiosyncratic liver disease attributed to colchicine use. Interestingly, liver biopsies done in patients receiving colchicine often show scattered mitotic figures in hepatocytes (ring mitoses) without accompanying liver cell injury.

In high doses, however, colchicine is associated with severe toxicity which can involve the liver. Intentional as well as accidental overdoses of colchicine can be severe and even fatal, usually presenting with vomiting, diarrhea, weakness and metabolic acidosis followed by rhadbomyolysis, shock, sepsis, coma and multiorgan failure. Liver test abnormalities can occur but may be due to rhabdomyosis rather than liver injury. Acute liver failure may arise later, perhaps as a result of shock and multiorgan failure. Colchicine overdose is rarely associated with frank jaundice or with a hepatitis-like presentation. The liver abnormalities are probably secondary to ischemic injury to the liver or sepsis.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of colchicine hepatotoxicity is believed to be inhibition of microtubule or spindle formation and mitotic arrest. Indeed, colchicine is used in the laboratory to inhibit microtubular function and for mitotic chromosomal preparations. Colchicine undergoes extensive hepatic metabolism and hepatic adverse events might be more common without the safety valve of gastrointestinal side effects. Colchicines hepatic safety is probably due to the low daily dose taken (less than 1 mg daily).

### Outcome and Management

Cases of acute liver injury attributed to colchicine overdose have been self-limited, and the other toxicities of this agent generally overshadowed the hepatic injury. No convincing instances of acute liver failure, vanishing bile duct syndrome or chronic liver injury due to colchicine have been reported.

Drug Class: Antigout Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Colchicine – Generic, Colcrys®

DRUG CLASS

Antigout Agents/Gout Suppressants

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=colchicine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Colchicine | 64-86-8 | C22-H25-N-O6 | Colchicine chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 26 October 2017

Zimmerman HJ. Drugs used to treat gout. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 543-4. (Expert review of hepatotoxicity published in 1999 states that: "despite long-term use of colchicine... , there is little evidence of its causing hepatic injury in humans").
Grosser T, Smyth E, FitzGerald G. Pharmacology of gout. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 994-1004. (Textbook of pharmacology and therapeutics).
Carr AA. Colchicine toxicity. Arch Intern Med 1965; 115: 29-33. (36 year old man given high doses of colchicine [1.2-4 mg daily] developed fever, bone marrow suppression, and sepsis with accompanying rise in alkaline phosphatase [13 to 34 U/L] and AST [to ~90 U/L] without jaundice, ultimately resolving). 14219498
Boruchow IB. Bone marrow depression associated with acute colchicine toxicity in the presence of hepatic dysfunction. Cancer 1966; 19: 541-3. (69 year old man with obstructive jaundice due to pancreatic cancer developed fatal colchicine toxicity after taking a total dose of 14 mg over 6 days, whereupon he developed fever, bone marrow suppression and hypotension; underlying liver disease may have predisposed to toxicity). 5933578
Bruns BJ. Colchicine toxicity. Australas Ann Med 1968; 17: 341-4. (14 year old girl took overdose of colchicine [30 mg] and developed abdominal pain, vomiting and diarrhea followed by fever, pancytopenia, confusion, and seizures [bilirubin 1.7 mg/dL, AST 152 U/L, normal Alk P], alopecia appearing during recovery). 5701926
Stemmermann GN, Hayashi T. Colchicine intoxication. A reappraisal of its pathology based on a study of three fatal cases. Hum Pathol 1971; 2: 321-32. (Three cases of unintentional overdose of colchicine accompanied by vomiting, diarrhea, abdominal pain and followed by metabolic acidosis, renal and bone marrow failure, hypotension, stupor, widespread bleeding and death; liver abnormalities and hepatic necrosis on autopsy were frequent; etiology appears to be arrest of mitoses causing gastrointestinal and bone marrow failure). 5095674
Ellwood MG, Robb GH. Self-poisoning with colchicine. Postgrad Med J 1971; 47: 129-38. (Two women, ages 16 and 35 years, with intentional colchicine overdose developed nausea, vomiting, dehydration and hypotension followed by alopecia several weeks later; fatal case had centrolobular hepatic necrosis and fat). 5576148
Domnguez de Villota E, Galdos P, Mosquera JM, Tomas MI. Colchicine overdose: an unusual origin of multiorgan failure. Crit Care Med 1979; 7: 278-9. (50 year old man took an overdose [30 mg] of colchicine and rapidly developed fever, diarrhea, vomiting, dehydration and hypotension with renal failure, acidosis, septicemia, and liver test abnormalities [bilirubin 0.7 rising to 6.6 mg/dL, AST 58 to 333 U/L, Alk P 91 to 667 U/L], but ultimate full recovery; sepsis and hypotension may have contributed to the liver abnormalities). 446061
Murray SS, Kramlinger KG, McMichan JC, Mohr DN. Acute toxicity after excessive ingestion of colchicine. Mayo Clin Proc 1983; 58: 528-32. (15 year old girl took 2.4 mg of colchicine and rapidly developed nausea, weakness, hypotension, acidosis, respiratory failure and bone marrow suppression [no mention of bilirubin, AST 481 U/L, Alk P 595 U/L], ultimate recovery, alopecia on day 12). 6876886
Rosalki SB, Foo AY. Alkaline phosphatase of possible renal origin identified in plasma after colchicine overdose. Clin Chem 1989; 35: 702-3. (27 year old woman with colchicine overdose developed rising Alk P [135 rising to 639 U/L], which on analysis was identified as renal in origin). 2702760
Baldwin LR, Talbert RL, Sampler R. Accidental overdose of insufflated colchicine. Drug Saf 1990; 5: 305-12. (29 year old man and girlfriend snorted colchicine mistaking it for methamphetamine and developed nausea, diarrhea, fever, bone marrow suppression, renal failure and mild enzyme elevations [AST 311 U/L, Alk P 460 U/L], rapidly resolving in patient; the girl friend died). 2375835
Putterman C, Ben-Chetrit E, Caraco Y, Levy M. Colchicine intoxication: clinical pharmacology, risk factors, features, and management. Semin Arthritis Rheum 1991; 21: 143-55. (Overview of history, chemistry, pharmacokinetics, and side effects of colchicine focusing on features and management of overdose; mentions that liver damage from colchicine is uncommon, but has been described). 1788551
Ben-Chetrit E, Levy M. Colchicine: 1998 Update. Semin Arthrit Rheum 1998; 28: 48-59. (Review of history, structure, pharmacology, efficacy, side effects and indications of colchicine; overdose can cause cholera-like syndrome of diarrhea, dehydration and shock with renal, cardiac, hepatic, and bone marrow failure). 9726336
Brvar M, Kozelj G, Mozina M, Bunc M. Acute poisoning with autumn crocus(Colchicum autumnale L.). Wien Klin Wochenschr 2004; 116: 205-8. (71 year old woman ate autumn crocus and developed nausea, diarrhea followed by anemia with AST and LDH levels rising to 8 times ULN, resolving quickly and followed by alopecia during recovery). 15088997
Livio Ndiaye F, Wiesel PH, Goy JJ, Genton A. [Abdominal pain and recurrent cholestatic jaundice] Praxis (Bern 1994) 2004; 93: 1051-4. French. (70 year old man with heart and kidney transplants, developed jaundice and abdominal pain 1 month after starting colchicine and allopurinol [bilirubin 14.3 mg/dL, ALT 60 U/L, Alk P 244 U/L], resolving with stopping; then had acute abdominal pain and jaundice after 3 days of high doses of colchicine [total dose 7 mg] with bilirubin 5.6 mg/dL, ALT 20 U/L, Alk P 229 U/L, recovering quickly). 15318531
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US between 2004 and 2008, more than 100 agents were implicated, but not colchicine). 18955056
Kamath A, Mehal W, Jain D. Colchicine-associated ring mitosis in liver biopsy and their clinical implications. J Clin Gastroenterol 2008; 42: 1060-2. (54 year old man with chronic hepatitis C taking colchicine [0.6 mg/day] had scattered mitotic figures in hepatocytes, in addition to chronic hepatitis on liver biopsy). 18391833
Montiel V, Huberlant V, Vincent MF, Bonbled F, Hantson P. Multiple organ failure after an overdose of less than 0.4 mg/kg of colchicine: role of coingestants and drugs during intensive care management. Clin Toxicol (Phila) 2010; 48: 845-8. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/20969505) (33 year old woman developed severe diarrhea and hypotension within 24 hours of taking an overdose of colchicine [20 mg], ibuprofen [8 g], diclofenac [1 g], atorvastatin [100 mg] and furosemide [400 mg] with progressive multiorgan failure [bilirubin 1.0 rising to 17.2 mg/dL, ALT 41 to 4710 U/L, CK 211 to 26,990 U/L] over the next 14 days and death).
Smith MW, Roberts DM, Ritson SM, Day RO. Death and morbidity from supratherapeutic dosing of colchicine. Med J Aust 2011; 194: 612-3. (Short descriptions of 3 patients who developed severe nausea, vomiting, diarrhea, and myalgias within a few days of startng high doses of colchicine [2-4 mg daily]; one died of multiorgan failure, the other two recovered rapidly upon stopping, one had “hepatic dysfunction”). 21644880
Iosfina I, Lan J, Chin C, Werb R, Levin A. Massive colchicine overdose with recovery. Case Rep Nephrol Urol 2012; 2: 20-4. (47 year old woman took an overdose of colchicine [90 mg] and presented one hour later with abdominal pain, later developing respiratory, renal, cardiovascular and hepatic failure [AST rising from 29 to 15,111 U/L within 3 days], but ultimately recovered). 23197951
Little A, Tung D, Truong C, Lapinsky S, Burry L. Colchicine overdose with coingestion of nonsteroidal antiinflammatory drugs. CJEM 2014; 16: 252-6. (39 year old woman took an intentional multidrug overdose [25 mg colchicine, 1.25 g indomethacin, 75 mg zopiclone] and presented with severe nausea, vomiting and abdominal pain followed by shock, multiorgan failure and death 52 hours after the ingestion [ALT peak 1050 U/L, AST 4100 U/L, CPK 5,840 U/L, bilirubin not given]). 24852590
Aghabiklooei A, Zamani N, Hassanian-Moghaddam H, Nasouhi S, Mashayekhian M. Acute colchicine overdose: report of three cases. Reumatismo 2014; 65: 307-11. (Three cases of colchicine overdose, all presenting rapidly with nausea, abdominal pain and diarrhea, and two then developing metabolic acidosis, renal failure, cardiovascular collapse and death). 24705036
Fernández S, Castro P, Nogué S, Nicolás JM. [Refractory shock and severe leukopenia with multisystemic organ failure due to colchicine intentional overdose]. Med Clin (Barc) 2014; 143 (3): 140. Spanish. (24 year old man developed nausea and abdominal pain within hours of a colchicine overdose [30 mg], followed by acidosis and rhabdomyolysis [CPK 1128 U/L], bone marrow suppression, sepsis and then renal, cardioascular and pulmonary failure, dying 5 days after the ingestion). 24378151
Kilic SC, Alaygut D, Unal E, Koç E, Patiroglu T. Acute colchicine intoxication complicated with extramedullary hematopoiesis due to filgrastim in a child. J Pediatr Hematol Oncol 2014; 36: e460-2. (3 year old boy took an overdose of his mother's colchicine and developed nausea, vomiting and diarrhea followed by rhabdomyolysis, acidosis, neutropenia and sepsis, which was treated with recombinant G-CSF and was followed by leukocytosis and hepatomegaly which the authors attributed to extramedullary hematopoiesis). 24309614
Shuttleworth E, Sawyer R, Holland M, Cooksley T. The perils of Grandma's medication: colchicine toxicity causing pneumomediastinum. Acute Med 2014; 13: 171-3. (19 year old man took an overdose of colchicine [50 mg] and developed refractory vomiting followed by subcutaneous and mediastinum emphysema, bone marrow suppression [white count 1100/µ L, platelets 4000/µL], and coagulopathy [prothrombin time 17.9 sec], but recovered with supportive therapy only). 25521087
Boonstra JJ, Kan AA, de Vries I, Deneer VH, Meinders AJ. [A potentially fatal intoxication with colchicine]. Ned Tijdschr Geneeskd 2015; 159: A8144. Dutch. (18 year old woman took an overdose of colchicine [30 mg] and developed abdominal pain and vomiting followed by anema, thrombocytopenia and paralytic ileus requiring intensive care, but with ultimate recovery; no liver test results provided). 25804106
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to colchicine). 25754159
Arslan MN, Özgün A, Daş T, Kumru D, Şam B, Koç S. Colchicine-induced rhabdomyolysis: An Autopsy Case. Am J Forensic Med Pathol 2016; 37: 57-9. (18 year old woman with familial Mediterranean fever developed fatal rhabdomyolysis and shock after a colchicine overdose (4.5 mg), and had moderate fatty liver at autopsy). 27049658
Alaygut D, Kilic SC, Kaya A, Oflaz MB, Bolat F, Cevit Ö, Icagasioglu FD. Assessment of 17 pediatric cases With colchicine poisoning in a 2-year period. Pediatr Emerg Care 2016; 32: 168-72. (Over a 2 year period, 17 children, ages 1 to 17 years, were admitted to a Turkish referral center for colchicine overdose, 6 had Familial Mediterranean fever and the others had swallowed family members' drug, 8 were symptomatic with nausea, abdominal pain or diarrhea, serum enyzme elevations arose in 2 patients, but were likely due to rhabdomyolysis [peak ALT 119 and 646 U/L, AST 3357 and 3003, CPK 3700 and 75,643 U/L]; all survived). 26928096
Lloyd G. Colchicine in overdose. Br J Gen Pract 2016; 66: 605. (The author reminds readers: "Please be aware of the devasting consequences of a significant colchicine overdose"). 27884896
Roddy E, Mallen CD. Colchicine in overdose. Br J Gen Pract. 2017; 67: 61. (In answer to Lloyd [2016] "We urge prescribers not to abandon an effective treatment for this excruciatingly painful...condition"). 28126860

## OTHER REFERENCE LINKS

1. Recent References on Colchicine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Colchicine/AE+AND+Human%5BMH%5D+AND+(drug-induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+(%222010/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Colchicine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Colchicine)